# Tipranavir

## OVERVIEW

### Introduction

Tipranavir is an antiretroviral protease inhibitor used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Tipranavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and is a rare cause of clinically apparent, acute liver injury. In coinfected patients, hepatic injury during highly active antiretroviral therapy including tipranavir may be a result of exacerbation of the underlying chronic hepatitis B or C, rather than a direct effect of the medication.

### Background

Tipranavir (tye pran' a vir) a nonpeptidic antiretroviral protease inhibitor that acts by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Tipranavir was approved for use in the United States in adults in 2005 and for children in 2008 for the therapy of HIV infection in combination with other antiretroviral agents. Tipranavir is typically used in combination with low “booster” doses of ritonavir, which inhibits its hepatic metabolism and improves its pharmacokinetics. Tipranavir is available in capsules of 250 mg and as an oral solution (100 mg/mL) for pediatric use under the brand name Aptivus. The recommended dosage of tipranavir for adults is 500 mg in combination with ritonavir 200 mg, both taken twice daily. The dose in children is based upon body weight or body surface area. Common side effects include gastrointestinal upset, nausea, diarrhea, headache, fatigue and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking tipranavir containing antiretroviral regimens. Moderate-to-severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Clinically apparent liver injury from tipranavir is rare, and the clinical pattern of liver injury, latency and recovery have not been well defined. Several protease inhibitors have been associated with acute liver injury arising 1 to 8 weeks after onset, with variable patterns of liver enzyme elevation, from hepatocellular to cholestatic. Immunoallergic features (rash, fever, eosinophilia) are uncommon, as is autoantibody formation. The acute liver injury due to tipranavir is usually self-limited, but it can be severe, and isolated cases of acute liver failure have been reported to the sponsor. In HBV or HCV coinfected patients, some instances appear to be due to exacerbation of the underlying chronic liver disease, perhaps as a result of sudden immune reconstitution. Tipranavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors. Thus, tipranavir is associated with a high rate of serum enzyme elevations which is generally higher than with other protease inhibitors, for which reason it is considered a second-line HIV protease inhibitor.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from tipranavir is not known. Tipranavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP3A4), and toxic intermediates may be the cause of some liver injury. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug.

### Outcome and Management

The severity of the liver injury from tipranavir ranges from mild and transient enzyme elevations to more marked and symptomatic enzyme elevations and, rarely, to acute hepatitis which is usually self-limited, but can result in acute liver failure and death. For these reasons, routine monitoring with liver tests done before and at regular intervals is recommended for patients taking tipranavir. Improvements in serum aminotransferase elevations usually start within a few days of stopping therapy and recovery is usually rapid. Rechallenge may lead to recurrence and should be avoided. There is little evidence for cross reactivity to the hepatotoxicity of tipranavir with other protease inhibitors or antiretroviral agents. The exacerbation of hepatitis B or C that can occur with tipranavir based combination antiretroviral therapies can be severe and lead to acute liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to tipranavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir

## CASE REPORT

### Case 1. Serum enzyme elevations during tipranavir/ritonavir therapy.

[Modified from: Jülg B, Bogner JR, Goebel FD. Severe hepatotoxicity associated with the combination of enfuvirtide and tipranavir/ritonavir: case report. AIDS 2006; 20:1563. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16847416)]

A 52 year old man with long standing HIV-HBV coinfection and exposure to multiple antiretroviral agents developed serum aminotransferase elevations 2 weeks after having tipranavir/ritonavir added to a chronic regimen of zidovudine, lamivudine and enfuvirtide. Serum enzymes, which had been normal before therapy, included ALT 538 U/L and GGT 238 U/L. A liver biopsy was done that showed mild hepatitis and no steatosis. At the patient’s request, enfuvirtide rather than tipranavir was stopped, and serum enzymes decreased by 50%. Serum GGT levels increased and, at this point, tipranavir was stopped, whereupon all liver tests returned to normal during the next 4 weeks. Serial levels of HBV DNA were not available, but at the height of the enzyme elevations, HBV DNA was 20,000 copies/mL.

#### Key Points

Medication: | Tipranavir/ritonavir
Pattern: | Hepatocellular (R=5.5, based upon GGT results)
Severity: | Mild (ALT elevations without jaundice)
Latency: | 2 weeks
Recovery: | 4 weeks
Other medications: | Ritonavir, zidovudine, lamivudine, enfuvirtide

#### Comment

A complex course in a patient with multidrug resistant HIV infection on five antiretroviral agents. Serum ALT levels rose after addition of tipranavir to his chronic antiviral regimen. Stopping enfuvirtide was followed by partial improvement in liver tests, but complete resolution came only with stopping tipranavir. Tipranavir with low dose ritonavir has been associated with prominent ALT elevations (at least 5 times the upper limit of the normal range) in up to 10% of patients. In this instance, the enzyme elevations did not resolve until tipranavir was stopped. In the absence of serial testing of serum enzymes, bilirubin, HIV levels, CD4 counts as well as HBV DNA (with HBeAg and anti-HBe testing), the role of an exacerbation of the underlying chronic hepatitis B caused by immune reconstitution cannot be excluded.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tipranavir – Aptivus®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tipranavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tipranavir | 174484-41-4 | C31-H33-F3-N2-O5-S | Tipranavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Tipranavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tipranavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tipranavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tipranavir)